# Abacavir

## OVERVIEW

### Introduction

Abacavir sulfate is a nucleoside analogue and reverse transcriptase inhibitor which is used in combination with other agents in the therapy of the human immunodeficiency virus (HIV) infection and the acquired immunodeficiency syndrome (AIDS). Abacavir is a rare cause of clinically apparent drug induced liver injury.

### Background

Abacavir (a bak' a vir) (cyclopropylaminopurinylcyclopentene: ABC) is a structural analogue of guanosine and acts by competing with naturally occurring nucleosides for incorporation into the HIV DNA strand during viral replication, causing inhibition of the viral polymerase and chain termination. Abacavir is indicated for the treatment of HIV infection in combination with other HIV medications such as lamivudine and zidovudine. Abacavir is available generically and under the trade name Ziagen in a 20 mg/mL oral solution and a 300 mg oral tablet. Abacavir is also available in fixed combination with lamivudine as Epzicom and Kivexa, with zidovudine and lamivudine as Trizivir and with dolutegravir and lamivudine as Triumeq. The recommended dose of abacavir is 300 mg orally twice daily or 600 mg orally once daily in adults and 8 mg/kg orally twice daily in children larger than 15 kg, with a maximum daily dose of 300 mg. Abacavir was approved for use in the United States in 1998 and is currently used in many antiretroviral regimens. Common side effects include diarrhea, loss of appetite, nausea, headache, and fatigue.

### Hepatotoxicity

Elevations in serum aminotransferase levels above 5 times the upper limit of normal occur in up to 6% of patients on abacavir. These elevations are usually mild, transient and do not require dose adjustment. Clinically apparent hepatotoxicity is rare, but isolated cases [usually anicteric] have been published. The liver injury usually arises in the context of abacavir hypersensitivity syndrome and may be overshadowed by the allergic syndromes of fever, rash and fatigue. The onset is usually within 1 to 3 months of starting abacavir. The serum enzyme pattern can be hepatocellular or cholestatic. Patients typically recover rapidly within 4 weeks of stopping therapy.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the clinically apparent hepatotoxicity from abacavir is hypersensitivity in some cases and is typically associated with the HLA-B*57:01 haplotype. Abacavir binds to the antigen-binding cleft of the HLA-B*57:01 molecule and alters its peptide binding repertoire. Testing for this allele is available in the United States and is recommended before starting abacavir. There are few cases of nonhypersensitivity abacavir induced hepatitis (Case 1) in which the mechanism is unknown.

### Outcome and Management

Most cases of liver injury associated with abacavir have been mild and anicteric and resolved rapidly within 4 weeks of discontinuation. There have been no convincing published cases of acute liver failure or vanishing bile duct syndrome due to abacavir. Patients with hepatotoxicity due to abacavir can generally tolerate other antiretroviral agents, rechallenge should be avoided, particularly in cases with features of hypersensitivity.

Drug Class: Antiviral Agents, Antiretroviral Agents

Other Drugs in the Subclass, Nucleoside Analogues: Adefovir, Didanosine, Emtricitabine, Entecavir, Lamivudine, Stavudine, Telbivudine, Tenofovir, Zidovudine

## CASE REPORT

### Case 1. Abnormal liver function tests occurring in a young HLA B*5701-negative woman shortly after switching to abacavir.

[Modified from: Soni S, Churchill DR, Gilleece Y. Abacavir-induced hepatotoxicity: a report of two cases. AIDS 2008; 22: 2557-8. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/19005287)]

A 26 year old woman switched from a regimen of zidovudine, lamivudine and nevirapine to abavir/lamivudine/nevirapine and developed nausea six weeks later, but continued on therapy for another month when liver tests were found to be abnormal. Before starting abacavir, she had tested negative for the HLA B*57:01 allele and had normal serum aminotransferase levels. She did not drink alcohol to excess and had no history of liver disease. Serological testing showed no evidence of acute or chronic hepatitis B or C and she tested positive for anti-HAV and anti-HBs, indicative of previous vaccinations. On presentation, serum ALT was 433 U/L. Nevirapine was stopped, but she did not improve and a liver biopsy was done showing severe acute hepatitis with lobular collapse, changes suggestive of drug induced liver injury. Abacavir was discontinued and her symptoms quickly improved. Serum aminotransferases returned to normal 4 weeks later.

#### Key Points

Medication: | Abacavir
Pattern: | Hepatocellular
Severity: | 1+ (no jaundice)
Latency: | 4 weeks
Recovery: | 4 weeks
Other medications: | Nevirapine, lamivudine, lopinavir

#### Comment

While liver injury as a part of the hypersensitivity reaction to abacavir is most common in persons with the HLA B*57:01 allele, hepatotoxicity can occur without frank hypersensitivity in other individuals. The injury in this case arose after 6 weeks of therapy, although the presence of liver disease was not suspected until several weeks later. The patient did not become jaundiced (bilirubin levels were not mentioned), but the severity of the illness was shown by liver biopsy findings and manifested by the presence of persistent symptoms. Elevations in serum aminotransferase levels are common during antiretroviral therapy and do not always warrant dose adjustment of drug-continuation. However, the co-occurrence of clinical symptoms and serum aminotransferase elevations is usually indicative of moderate or severe injury and should trigger investigation and alteration in drug regimen.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Abacavir – Ziagen®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=abacavir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Abacavir | 136470-78-5 | C14-H18-N6-O | Abacavir Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 04 January 2016

Núñez M. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents including the nucleoside reverse transcriptase inhibitors).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1623-64. (Textbook of pharmacology and therapeutics).
http://aidsinfo.nih.gov/guidelines. (Clinical guidelines on the use of antiretroviral agents in HIV-1 infected adults, adolescents and children).
Lewis W, Dalakas MC. Mitochondrial toxicity of antiviral drugs. Nature Med 1995; 1: 417-23. (Review of mechanisms for mitochondrial injury by nucleoside analogues, including inhibition of mitochondrial DNA polymerase gamma). 7585087
Brinkman K, ter Hofstede HJ, Burger DM, Smeitink JAM, Koopmans PP. Adverse effects of reverse transcriptase inhibitors: mitochondrial toxicity as a common pathway. AIDS 1998; 12: 1735-44. (Review of mitochondrial function and role of mitochondrial toxicity or depletion in the adverse side effects of nucleoside analogues). 9792373
Sulkowski MS, Thomas DL, Chaisson RE, Moore RD. Hepatotoxicity associated with antiretroviral therapy in adults infected with human immunodeficiency virus and the role of hepatitis C or B virus infection. JAMA 2000; 283: 74-80. (Among 298 patients with HIV infection, ALT elevations above 5 times ULN occurred in 10.4% per year during antiretroviral treatment; factors associated with ALT elevations included ritonavir [27.3%] and coinfection with either HCV or HBV; ALT with bilirubin elevations occurred in 3 patients; 2 on indinavir and all 3 with coinfection). 10632283
Velasco M, Guijarro C. Elevated liver enzymes following initiation of antiretroviral therapy. JAMA 2000; 283: 2526-7. (Letter in response to Sulkowski et al. [JAMA 2000] pointing out that antiretroviral therapy can cause immune reconstitution and flares of hepatitis B or C which may be misdiagnosed as hepatotoxicity). 10815112
Sulkowski MS, Thomas DL, Chaisson RE, Moore RD. Elevated liver enzymes following initiation of antiretroviral therapy JAMA 2000; 283: 2526-7. (Reply to Velasco and Guijarro pointing out that the majority of the ALT elevations described could not be attributed to immune reconstitution). 10815113
Hetherington S, McGuirk S, Powell G, Cutrell A, Naderer O, Spreen B, Lafon S, et al. Hypersensitivity reactions during therapy with nucleoside reverse transcriptase inhibitor abacavir. Clin Ther 2001; 23: 1603-14. (Among ~200,000 patients treated with abacavir, 1803 had a suspected hypersensitivity reaction [4.3% of those in clinical trials] marked by fever, rash, fatigue and GI upset, mostly within 1-3 weeks of starting abacavir; 14% had accompanying liver test abnormalities). 11726000
Mallal S, Nolan D, Witt C, Masel G, Martin AM, Moore C, Sayer D, et al. Association between presence of HLA-B*5701, HLA-DR7, and HLA-DQ3 and hypersensitivity to HIV-1 reverse transcriptase inhibitor abacavir. Lancet 2002; 359: 727-32. (Among 200 Australian patients started on abacavir, 18 developed hypersensitivity, 14 [78%] of whom had HLA-B*57:01 vs 2% [4/167] of controls). 11888582
Hetherington S, Hughes ARR, Mosteller M, Shortino D, Baker KL, Spreen W, Lai E, et al. Genetic variations in HLA-B region and hypersensitivity reactions to abacavir. Lancet 2002; 1121-2. (Case controlled study found HLA-B57 in 46% of 84 patients with abacavir hypersensitivity vs 4% of 113 controls; more significant in whites than blacks). 11943262
Spengler U, Lichterfeld M, Rockstroh JK. Antiretroviral drug toxicity.a challenge for the hepatologist? J Hepatol 2002; 36: 283-94. (Review of the diagnosis of drug induced liver disease in patients with HIV on antiretroviral agents with discussion of mechanisms including mitochondrial toxicity and hypersensitivity reactions). 11830343
Dumouchel-Champagne H, Bouhour D, Ferry T, Durupt F, Granier P. Rétion d'hypersensibilité l'abacavir ou hétite syphilitique? Presse Med 2003; 32: 1577-8. (24 year old man developed rash and fever 15 days after starting abacavir with ALT 129 U/L and Alk P 299 U/L; there was no response to stopping abacavir and he was later found to have syphilis). 14576594
Kontorinis N, Dieterich D. Hepatotoxicity of antiretroviral therapy. AIDS Rev 2003; 5: 36-43. (Review of hepatotoxicity of antiretroviral drugs; definition of hepatotoxicity in antiretroviral studies; grade 1=1.25-2.5 times, grade 2=2.6-5 times, grade 3=5.1-10 times and grade 4=>10 times normal or baseline ALT values; abacavir and lamivudine are least likely to cause hepatotoxicity). 12875106
Ogedegbe AO, Sulkowski MS. Antiretroviral-associated liver injury. Clin Liver Dis 2003; 7: 475-99. (Review of hepatotoxicity of antiretrovirals; ALT elevations above 5 times ULN reported in 7% with zidovudine, 16% didanosine, 9-13% stavudine, <1% lamivudine, tenofovir and abacavir, 3-10% protease inhibitors, 10% nevirapine and 8% efavirenz; recommends monitoring at 4 weeks and then every 12 weeks, stopping if ALT levels are >10 times ULN or if symptoms of liver injury are present, monitoring more closely if ALT levels are elevated). 12879995
Ofotokun I, Pomeroy C. Sex differences in adverse reactions to antiretroviral drugs. Top HIV Med 2003; 11: 55-9. (Review of sex differences in adverse events; mentions a higher frequency of mitochondrial toxicity and hypersensitivity in women than men). 12717043
Lonergan JT, McComsey GA, Fisher RL, Shalit P, File TM Jr, Ward DJ, Williams VC, et al. for the ESS40010(TARHEEL) Study Team. Lack of recurrence of hyperlactatemia in HIV-infected patients switched from stavudine to abacavir or zidovudine. J Acquir Immune Defic Syndr 2004; 36: 935-42. (Prospective study of 118 patients with HIV infection on stavudine who switched to abacavir or zidovudine; lactate levels fell upon stopping stavudine and despite starting other agents; few were markedly hyperlactatemic). 15220700
Giola M, Basilico C, Grossi P. Fatal lactic acidosis associated with tenofovir and abacavir. Int J Infect Dis 2005; 9: 228-9. (60 year old man developed fatal lactic acidosis and liver injury 5 months after being switched from stavudine to abacavir while continuing tenofovir and nevirapine [ALT 70 U/L, lactate 9.7 micromol], and progressive acidosis). 15916912
Abrescia N, D.Abbraccio M, Figoni M, Busto A, Maddaloni A, De Marco M. Hepatotoxicity of antiretroviral drugs. Curr Pharm Des 2005; 11: 3697-710. (Review of hepatotoxicity of antiretrovirals; major syndrome with nucleoside analogues is mitochondrial injury with lactic acidosis and severe hepatomegaly and steatosis). 16305505
Stekler J, Maenza J, Stevens C, Holte S, Malhotra U, McElrath MJ, Corey L, et al. Abacavir hypersensitivity reaction in primary HIV infection. AIDS 2006; 20: 1269-74. (Among 50 men with acute HIV infection treated with a regimen including abacavir, 9 [18%] developed symptoms of hypersensitivity [rash, fever, fatigue] 1-60 days after starting, but all resolved and no mention of hepatotoxicity; only two had HLA B* 57:01). 16816555
Bourlière M, Duclos-Vallé JC, Pol S. [Liver and antiretrovirals: hepatotoxicity, steatosis and monitoring of patients with liver disease] Gastroenterol Clin Biol 2007; 31: 895-905. French. (Review of hepatotoxicity of antiretrovirals in French discussing patterns of idiosyncrasy, hypersensitivity [nevirapine and abacavir], mitochondrial toxicity [zalcitabine, didanosine, stavudine, zidovudine], steatohepatitis [protease inhibitors with lipodystrophy], immune restoration [in patients with HBV or HCV coinfection], recommendations for management focusing on prevention and monitoring). 18166875
Jain MK. Drug-induced liver injury associated with HIV medications. Clin Liver Dis 2007; 11: 615-39, vii-viii. (Review of hepatotoxicity of antiretroviral drugs; ALT elevations occur in 2-18% of patients, but often resolve spontaneously even without dose modification; classes of injury include hypersensitivity [nevirapine, efavirenz, abacavir], mitochondrial injury [stavudine, didanosine, zidovudine], flares of hepatitis B [lamivudine, emtricitabine, tenofovir], flares of hepatitis C [any potent regimen], idiosyncratic injury [ritonavir, nevirapine, efavirenz], cholestatic hepatitis [many agents]). 17723923
Esser S, Helbig D, Hillen U, Dissemond J, Grabbe S. Side effects of HIV therapy. J Dtsch Dermatol Ges 2007; 5: 745-54. (Review of side effects of antiretroviral agents focusing on immune reconstitution syndrome, lipodystrophy, cutaneous skin reactions, hypersensitivity reactions [abacavir, nevirapine], hyperbilirubinemia [indinavir, atazanavir], local reactions [enfuvirtide] and hyperpigmentation [zidovudine, emtricitabine]). 17760894
Waters LJ, Mandalia S, Gazzard B, Nelson M. Prospective HLA-B*5701 screening and abacavir hypersensitivity: a single centre experience. AIDS 2007; 21: 2533-4. (Hypersensitivity reactions to abacavir occurred in only 2% of HLA-B*57:01-negative patients; symptoms included fever, rash and gastrointestinal upset). 18025891
FDA notifications. Abacavir package insert changes approved. Hypersensitivity, other issues addressed. AIDS Alert 2008; 23: 102-4. (FDA update regarding adverse effects of abacavir). 18939305
Mallal S, Phillips E, Carosi G, Molina JM, Workman C, Tomazic J, Jäl-Guedes E, et al.; PREDICT-1 Study Team. HLA-B*5701 screening for hypersensitivity to abacavir. N Engl J Med 2008; 358: 568-79. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%2018256392) (Prospective trial of screening for HLA-B*57:01 in 1956 patients given abacavir; hypersensitivity reactions occurred in 7.8% of unscreened controls vs 3.4% of screened; but immunologically confirmed cases occurred only in unscreened group [2.7% vs 0%]).
Soni S, Churchill DR, Gilleece Y. Abacavir-induced hepatotoxicity: a report of two cases. AIDS 2008; 22: 2557-8. (Two cases of anicteric liver injury [peak ALT 433 and 580 U/L] after 2-3 months of abavir therapy, both patients did not have HLA-B*57:01 and both resolved within 4 weeks of stopping: Case 1). 19005287
Hughes CA, Foisy MM, Dewhurst N, Higgins N, Robinson L, Kelly DV, Lechelt KE. Abacavir hypersensitivity reaction: an update. Ann Pharmacother 2008; 42: 387-96. (Review of abacavir hypersensitivity; occurs in ~5% of patients exposed, usually in first 6 weeks [mean=11 days], worsening if continued and improving in 2-3 days of stopping, fever in 80%, rash in 70%, fatigue, myalgias, headache, diarrhea, itching, respiratory symptoms, dyspnea, or pharyngitis and liver test abnormalities occasionally; linked to HLA-B*57:01, which is found in 8% of European whites, <1% of Africans; confirmed cases rare in HLA-B57-negative subjects). 18303141
Hammer SM, Eron JJ Jr, Reiss P, Schooley RT, Thompson MA, Walmsley S, Cahn P, et al.; International AIDS Society-USA. Antiretroviral treatment of adult HIV infection: 2008 recommendations of the International AIDS Society-USA panel. JAMA 2008; 300: 555-70. (Updated recommendations on use of antiviral therapy in adults with HIV infection including use of recently approved agents raltegravir, maraviroc and etravirine). 18677028
Inductivo-Yu I, Bonacini M. Highly active antiretroviral therapy-induced liver injury. Current Drug Safety 2008; 3: 4-13. (Review of drug induced liver injury due to antiretroviral agents). 18690975
Soriano V, Puoti M, Garcia-Gascó Rockstroh JK, Benhamou Y, Barreiro P, McGovern B. Antiretroviral drugs and liver injury. AIDS 2008; 22: 1-13. (Review of hepatotoxicity of antiretrovirals with recommendations on management, stopping therapy if symptoms arise, with overt jaundice [direct bilirubin], evidence of mitochondrial toxicity, ALT >10 times ULN, ALT at lower levels if newly marketed agent; important to rule out other causes: problematic agents include didanosine, stavudine and zidovudine; nevirapine and efavirenz, full dose ritonavir and tipranavir). 18090386
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 7 were attributed to antiretroviral agents, 2 nevirapine, 1 efavirez and 4 miscellaneous combinations). 18955056
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, 3 antiretroviral agents were among the top 40 causes, including zidovudine [8th, 106 cases], lamivudine [26th, 45 cases] and nevirapine [36th, 37 cases]). 21039766
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (313 cases of drug induced liver injury were seen between 1997 and 2008 at a large hospital in Bangalore, India; none were attributed to antiretroviral agents). 20648003
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 4 to antiretroviral agents, including 3 to combinations with stavudine and 1 to abacavir). 20949552
Molleston JP, Fontana RJ, Lopez MJ, Kleiner DE, Gu J, Chalasani N: Drug-induced Liver Injury Network. Characteristics of idiosyncratic drug-induced liver injury in children: results from the DILIN prospective study. J Pediatr Gastroenterol Nutr 2011; 53: 182-9. (Among 30 children with suspected drug induced liver injury, none were attributed to an antiretroviral agent). 21788760
Sanchez-Giron F, Villegas-Torres B, Jaramillo-Villafuerte K, Silva-Zolezzi I, Fernandez-Lopez JC, Jimenez-Sanchez G, Carnevale A. Association of the genetic marker for abacavir hypersensitivity HLA-B*5701 with HCP5 rs2395029 in Mexican Mestizos. Pharmacogenomics 2011; 12: 809-14. (HLA-B*57:01 was identified in 2% of Mexican Mestizos and was in complete linkage disequilibrium with HCP5 rs2395029). 21510768
Kostenko L, Kjer-Nielsen L, Nicholson I, Hudson F, Lucas A, Foley B, Chen K, et al. Rapid screening for the detection of HLA-B57 and HLA-B58 in prevention of drug hypersensitivity. Tissue Antigens 2011; 78: 11-20. (Description of a monoclonal antibody reactive to HLA-B57 and B58 that was reliable in screening peripheral blood lymphocytes for these HLA alleles and might be used clinically). 21501118
Trottier B, Machouf N, Thomas R, Gallant S, Longpré D, Vézina S, Boissonnault M, Lavoie S, Legault D, Dion H, Nguyen VK. Abacavir/lamivudine fixed-dose combination with ritonavir-boosted darunavir: a safe and efficacious regimen for HIV therapy. HIV Clin Trials 2012; 13: 335-42. (Among 65 patients with HIV infection [HLA-B*57:01 negative] treated with lamivudine, abacavir and darunavir with ritonavir for 48 weeks, none developed ALT elevations greater than 3 times ULN). 23195671
Illing PT, Vivian JP, Dudek NL, Kostenko L, Chen Z, Bharadwaj M, Miles JJ, et al. Immune self-reactivity triggered by drug-modified HLA-peptide repertoire. Nature 2012; 486(7404): 554-8. (Abacavir binds specifically to HLA-B*57:01, lying across the bottom of the antigen binding clerft, changing its shape and chemistry and altering the repertoire of peptides that can bind and be presented by HLA-B*57:01). 22722860
Kaniwa N, Saito Y. Pharmacogenomics of severe cutaneous adverse reactions and drug-induced liver injury. J Hum Genet 2013; 58: 317-26. (Review of genetics of severe cutaneous adverse reactions, including hypersensitivity reactions to abacavir which has been linked closely to HLA-B*57:01 in both Caucasian and African populations). 23635947
Borghi V, Bisi L, Manzini L, Cossarizza A, Mussini C. Absence of liver steatosis in HIV-HCV co-infected patients receiving regimens containing tenofovir or abacavir. Infection 2013; 41: 425-9. (Analysis of liver biopsies from 205 patients with HIV/HCV coinfection found significant steatosis [>5%] in 48% and its presence was associated with HCV genotype 3 and exposure to stavudine, but not to abacavir, lamivudine, didanosine or tenofovir). 23225268
Illing PT, Vivian JP, Purcell AW, Rossjohn J, McCluskey J. Human leukocyte antigen-associated drug hypersensitivity. Curr Opin Immunol 2013; 25: 81-9. (Review of the basis of T cell activation by the interaction of abacavir with the antigen presenting HLA motif of B*57:01, abacavir appearing to alter the nature of the peptides that were accomodated in the antigen binding cleft of the HLA allele). 23141566
Di Filippo E, Ripamonti D, Rizzi M. Abacavir-induced liver toxicity in an HIV-infected patient. AIDS 2014; 28: 613. (37 year old man without HLA B*57:01 was found to have raised serum enzymes without symptoms or allergic manifestations 8 weeks after switching from zidovudine to abacavir [ALT 770 U/L, bilirubin and Alk P not given], improving rapidly on switching back to zidovudine). 24469001
Daly AK. Human leukocyte antigen (HLA) pharmacogenomic tests: potential and pitfalls. Curr Drug Metab 2014; 15: 196-201. (Review of use of HLA typing to avoid adverse drug reactions, discusses the role of HLA-B*57:01 before prescribing abacavir and HLA-B*15:02 before prescribing carbamazepine in East Asians). 24694233
Haas C, Ziccardi MR, Borgman J. Abacavir-induced fulminant hepatic failure in a HIV/HCV co-infected patient. BMJ Case Rep 2015; 2015. (50 year old man with HIV-HCV coinfection who had HLA-B*57:01 developed nausea and myalgias 2 weeks after switching to abacivr, dolutegravir and lamivudine [Triumeq] and subsequently developed acute liver and renal dysfunction [bilirubin not given, ALT 310 U/L, INR 2.3, creatinine 3.1 mg/dL, CPK 6896 U/L], responding rapidly to stopping abacavir and hydration; probably rhabdomyolysis more than hepatic failure). 26670894
Yip VL, Alfirevic A, Pirmohamed M. Genetics of immune-mediated adverse drug reactions: a comprehensive and clinical review. Clin Rev Allergy Immunol 2015; 48(2-3): 165-75. (Review and update of genetic associations with severe drug adverse events including abacavir hypersensitivity reactions and HLA-B*57:01). 24777842
Lin KY, Liao SH, Liu WC, Cheng A, Lin SW, Chang SY, Tsai MS, et al. Cholelithiasis and nephrolithiasis in HIV-positive patients in the era of combination antiretroviral therapy. PLoS One 2015; 10 :e0137660. (Review of records of 910 patients with HIV infection who underwent abdominal ultrasonography over an 11 year period, 680 of whom had a second examination, found 4.3% had developed cholelithiasis which in multivariate analysis was associated with atazanavir/r therapy and older age while new onset nephrolithiasis occurred in 3.7% and was associated with chronic hepatitis B or C, hyperlipidemia and exposure to abacavir). 26360703
Michels AW, Ostrov DA. New approaches for predicting T cell-mediated drug reactions: A role for inducible and potentially preventable autoimmunity. J Allergy Clin Immunol 2015; 136: 252-7. (Review of the pathogenesis and HLA associations of severe drug adverse events with features of hypersensitivity and their similarity to spontaneous autoimmune diseases). 26254052
Pirmohamed M, Ostrov DA, Park BK. New genetic findings lead the way to a better understanding of fundamental mechanisms of drug hypersensitivity. J Allergy Clin Immunol 2015; 136: 236-44. PubMed (Update and review of HLA associations with serious drug reactions including abacavir hypersensitivity which appears to the T-cell mediated and linked to HLA-B*57:01). 26254050
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-1352. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to abacavir). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Abacavir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Abacavir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Abacavir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Abacavir)